# Clinical Outcomes

Most cases of drug induced liver injury ultimately resolve completely without residual liver injury or liver test abnormalities. Three major exceptions include the progression to acute liver failure, the evolution to vanishing bile duct syndrome, and development of chronic liver injury and cirrhosis. These serious consequences of drug induced liver injury are fortunately rare, but they can develop even though the causative agent is stopped promptly. Importantly, these outcomes can result in death or need for liver transplantation.

Acute Liver Failure

Vanishing Bile Duct Syndrome

Cirrhosis